# Zileuton

## OVERVIEW

### Introduction

Zileuton is an antiinflammatory leukotriene pathway inhibitor classified as an inhibitor of the enzyme 5-lipoxygenase that is used in the treatment of asthma and allergic rhinitis. Zileuton has been linked to rare cases of drug induced liver disease and is considered to be contraindicated in patients with active liver disease.

### Background

Zileuton (zye loo' ton) is an inhibitor of the enzyme 5-lipoxygenase which is responsible for the conversion of arachidonic acid into leukotriene A4, a potent mediator of the inflammatory cascade that plays a central role in asthma and allergic rhinitis. Zileuton has been shown to ameliorate the symptoms of asthma and allergic rhinitis and was approved for use in the United States in 1996. Current indications include the prophylaxis and chronic treatment of asthma in adults and children 12 years of age and older. Zileuton is available in 600 mg tablets under the commercial name Zyflo. An extended release form is also available. The recommended dosage is 2400 mg daily. Common side effects include indigestion, nausea, abdominal discomfort, diarrhea, headache, insomnia and urticaria.

### Hepatotoxicity

In premarketing studies, zileuton therapy was found to be associated with mild-to-moderate serum aminotransferase elevations. In large prospective studies, ALT elevations above 3 times the upper limit of the normal range occurred in 1.9% of patients treated with zileuton for at least one year, compared to 0.2% of placebo recipients. These elevations were usually transient, asymptomatic and rapidly reversible. However, some patients with ALT elevations reported symptoms suggestive of hepatic injury (fatigue, nausea, abdominal pain) and individual cases of clinically apparent, frank liver injury with jaundice were seen. The typical onset of liver enzyme elevations was within 4 to 8 weeks of starting zileuton, but cases arising after 6 months were also reported. In cases with jaundice, the pattern of serum enzyme elevations was hepatocellular. Immunoallergic and autoimmune features were not prominent. Recovery was rapid, usually within 1 to 2 months. Overall, however, only isolated cases of zileuton related liver injury with jaundice have been reported, and clinically apparent hepatotoxicity from it must be very rare. Results of rechallenge have not been reported. Because of the frequency of serum enzyme elevations during zileuton therapy, monitoring of serum aminotransferase levels is recommended and its use is considered contraindicated in patients with active liver disease. The lack of published reports of zileuton hepatotoxicity may be due to active monitoring for liver test abnormalities and prompt discontinuation if they persist or continue to rise. In addition, zileuton has not been as widely used clinically as montelukast or zafirlukast.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism of liver injury due to zileuton is unclear, however in vitro studies suggest that reactive metabolites of zileuton can covalently bind to intracellular proteins and interfere with cellular functions. Thus, the most likely mechanism of liver injury is via reactive intermediates of metabolism.

### Outcome and Management

The serum elevations in serum aminotransferase levels which occur during zileuton therapy usually resolve rapidly (1 to 4 weeks) once therapy is stopped. Cases of clinical apparent liver injury resolve more slowly. Most instances of hepatic injury due to zileuton have been self-limited, but the potential for severe injury and hepatic failure must be considered particularly if the medication is not stopped promptly. Rechallenge may lead to recurrence and should be avoided.

Drug Class: Antiasthmatic Agents

## CASE REPORT

### Case 1. 28 year old woman with severe symptomatic liver injury during zileuton therapy.(1)

A 28 year old woman participating in a randomized controlled trial of zileuton (400 mg four times daily) versus placebo developed elevations in aminotransferase levels after 6 weeks of therapy. She reported symptoms of nausea and right upper quadrant pain. Serum bilirubin was 6.6 mg/dL, ALT 33 times the upper limit of normal (ULN), with minimal elevations in alkaline phosphatase (1.3 x ULN). Tests for viral hepatitis were negative and search for other causes of liver disease was unrevealing. The study drug was stopped, but serum bilirubin rose to 12.8 mg/dL before eventually falling to normal. Symptoms and laboratory abnormalities resolved within 35 days of stopping treatment.

#### Key Points

Medication: | Zileuton (400 mg four times daily)
Pattern: | Hepatocellular (R=25)
Severity: | 2+ (jaundice without hospitalization)
Latency: | 6 weeks (jaundice, increased enzymes)
Recovery: | 35-70 days
Other medications:

#### Laboratory Values

#### Comment

Despite being associated with a high rate of moderate-to-severe serum aminotransferase elevations, zileuton has rarely been reported to cause clinically apparent liver injury, outside of this analysis of premarketing studies of the drug. In that study, more than 2000 patients were treated with the drug, suggesting that the rate of clinically apparent liver injury with jaundice is less than 0.1%. During zileuton therapy, ALT elevations typically occurred during the first 1 to 3 months of therapy and were usually asymptomatic and self-limited. At least 15% of these elevations, however, were associated with nonspecific symptoms that might be considered liver related. The current case was the most dramatic example of injury found in the premarketing studies. The pattern of enzyme elevations was hepatocellular. Recovery was rapid with drug discontinuation.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zileuton – Zyflo CR®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=zileuton)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zileuton | 111406-87-2 | C11-H12-N2-O2-S

## CITED REFERENCE

1 Watkins PB, Dube LM, Walton-Bowen K, Cameron CM, Kasten LE. (2007). Clinical pattern of zileuton-associated liver injury: results of a 12-month study in patients with chronic asthma. Drug Saf.

## ANNOTATED BIBLIOGRAPHY

References updated: 18 July 2020

Zimmerman HJ. Respiratory supportive drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 717. (Expert review of hepatotoxicity published in 1999; mentions that theophylline has been incriminated in hepatic injury rarely; no mention of montelukast, zafirlukast or zileuton).
Lewis JH. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. pp. 389-90. (Expert review of liver injury caused by leukotriene receptor antagonists mentions that premarketing trials found elevations of ALT in 1.9% of zileuton- vs 0.2% of placebo-recipients and that a postmarketing study found such elevations in 4.6% vs 1.1%; yet no case reports of clinically apparent liver injury due to zileuton have been published since that time).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-49. (Textbook of pharmacology and therapeutics).
Israel E, Cohn J, Dubé L, Drazen JM. (1996). Effect of treatment with zileuton, a 5-lipoxygenase inhibitor, in patients with asthma. A randomized controlled trial. Zileuton Clinical Trial Group. JAMA. (Controlled trial of zileuton vs placebo for 13 weeks in 401 patients; ALT elevations >3x ULN in 4% on 600 mg, 2% on 400 mg and 0% on placebo, but no patient had clinically apparent hepatitis or jaundice and peak ALT values were only 110-386 U/L).
Lazarus SC, Lee T, Kemp JP, et al. (1998). Safety and clinical efficacy of zileuton in patients with chronic asthma. Am J Manag Care. (In a prospective study among 2947 patients, ALT elevations >3x ULN occurred in 4.6% of zileuton treated compared to 1.1% placebo recipients, usually arising in the first 2-3 months; no cases of jaundice or hepatitis were reported).
Drazen JM, Israel E, O’Byrne PM. (1999). Treatment of asthma with drugs modifying the leukotriene pathway. N Engl J Med. (Review article on leukotriene pathway in asthma and rhinitis and efficacy and safety of montelukast, zafirlukast and zileuton mentions that abnormal ALT elevations can occur).
Spector SL, Antileukotriene Working Group. (2001). Safety of antileukotriene agents in asthma management. Ann Allergy Asthma Immunol. (Review of side effects of antileukotrienes in premarketing studies mentions that ALT elevations [3 times ULN] occurred 1.4% of zafirlukast vs 1.1% of placebo recipients; in 2.1% on montelukast vs 2.0% of placebo recipients; and in 4.6% of zileuton recipients treated for a year [3 had hyperbilirubinemia] vs 1.1% of controls; but most were asymptomatic and all resolved when the medication was stopped).
Davern TJ, Bass NM. (2003). Leukotriene antagonists. Clin Liver Dis. (Review of literature on hepatotoxicity of leukotriene inhibitors; in premarketing studies, 1.5% of 4058 of zafirlukast vs 1.1% of placebo recipients had ALT elevations, none serious and all transient; review of literature identified 9 cases of zafirlukast hepatotoxicity, 7 with jaundice, 3 with rash and eosinophilia, arising after 1.5 to 13 months, with liver transplantation required in two).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure; one case was attributed to zafirlukast, but no other antiasthma medications were mentioned).
Joshi EM, Heasley BH, Chordia MD, Macdonald TL. (2004). In vitro metabolism of 2-acetylbenzothiophene: relevance to zileuton hepatotoxicity. Chem Res Toxicol. (In vitro studies revealed potential toxic intermediate of zileuton metabolism by liver microsomes: oxidative bioactivation of 2-ABT).
Watkins PB, Dube LM, Walton-Bowen K, Cameron CM, Kasten LE. (2007). Clinical pattern of zileuton-associated liver injury: results of a 12-month study in patients with chronic asthma. Drug Saf. (Further analysis of liver test results from study reported by Lazarus et al. [Am J Managed Care 1998]; ALT elevations of >3 times ULN occurred in 4.2% of zileuton vs 1.1% of placebo recipients; were >8 times ULN in 1.3% vs 0.2%; and >15 times ULN in 0.4% vs 0%; 70 of 109 episodes of ALT elevation began in the first 3 months of therapy, 16% were symptomatic, 2% were associated with bilirubin elevations >1.5 mg/dL).
Wenzel S, Busse W, Calhoun W, et al. (2007). The safety and efficacy of zileuton controlled-release tablets as adjunctive therapy to usual care in the treatment of moderate persistent asthma: a 6-month randomized controlled study. J Asthma. (Prospective trial of controlled release zileuton [n=619] vs placebo [n=307] for 6 months in patients with asthma found ALT elevations [>3x ULN] in 11 zileuton [1.8%] vs 2 on placebo [0.7%]; most ALT elevations within first 3 months, one had increased bilirubin; all evidently resolved).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiasthma medication).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 1 due to zafirlukast, but none were due to montelukast or zileuton).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to zileuton or other antiasthma medications).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to zileuton or any other medications for asthma).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [<1%] were attributed to medications for asthma, all due to montelukast and none to xanthine derivatives, zafirlukast or zileuton).
(2017). Drugs for asthma. Med Lett Drugs Ther. (Concise review of medications used for asthma including the leukotriene modifiers; mentions that zileuton and zafirlukast have been reported to cause life-threatening hepatic injury and that monitoring of liver tests during therapy is recommended).

## OTHER REFERENCE LINKS

1 Recent References on Zileuton: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Zileuton/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Zileuton: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zileuton)